# Mixed Hepatitis

Description. The course of drug induced liver injury is considered "mixed" if features of both hepatocellular (acute hepatitis) and cholestatic injury (cholestatic hepatitis) are present. The onset is typically within 2 to 12 weeks of starting the medication and is marked by fatigue, anorexia and nausea followed by jaundice and often pruritus. The liver enzyme pattern is characterized by moderate to marked elevations in both serum aminotransferases and alkaline phosphatase (Alk P), such that the R ratio (ALT divided by Alk P - both expressed as multiples of the upper limit of normal [ULN]) is between 2 and 5. The designation of "mixed" places the case between the extremes of hepatocellular vs. cholestatic injury and individual cases may tend to be one or the other. In general, mixed hepatitis cases of drug induced liver injury more closely resemble cholestatic cases, in their prolonged course and rare outcome of acute liver failure. This pattern of injury is very typical of drug induced liver injury, accounting for up to one third of cases.

Latency to Onset. The time to onset of mixed hepatitis is typically 2 to 12 weeks, but may occur up to one year after starting medication.

Symptoms. Symptoms usually begin with fatigue and nausea, followed soon after with pruritus, dark urine and jaundice. Immunoallergic features such as rash, fever and eosinophilia may occur.

Serum Enzyme Elevations. Prominent elevations in both alkaline phosphatase and ALT are present, such that the R ratio (ALT divided by Alk P - both expressed as multiples of the upper limit of normal) is between 2 and 5. Initially (at the time of onset) the R ratio may be higher, particularly when the time to onset is short. However, the case should be considered mixed based upon the majority of elevations during the period of illness or jaundice and not just based upon the initial value. Drug induced mixed cholestatic-hepatocellular liver injury is typically more prolonged than acute hepatitis due to medications, the serum enzymes decreasing slowly with 50% fall within 4 to 12 weeks. Prolonged jaundice may be followed by mild alkaline phosphatase elevations for months to years after symptomatic recovery (and loss of jaundice).

Drugs. Medications commonly implicated in causing mixed hepatitis include the aromatic anticonvulsants (phenytoin, carbamapezine, lamotrigine), nonsteroidal antiinflammatory agents, and many others. Drugs that typically cause and acute hepatitis like syndrome and those that typically cause cholestatic hepatitis can also cause a mixed enzyme pattern.

Differential Diagnosis. A mixed pattern of serum enzyme elevations accompanying acute jaundice is most likely due to drug induced liver disease; few other liver conditions give this distinctive pattern of enzyme elevations. Confusion may arise in patients with acute viral hepatitis, later in the course of illness and in acute biliary obstruction early and close to the time of onset. Acute mononucleosis and secondary syphilis occasionally present with jaundice and a mixed pattern of serum enzyme elevations, but other features of those infections usually overshadow the liver injury.

Criteria for Definition. Elements important in diagnosis of mixed hepatitis due to medications include:

1 A mixed pattern of serum enzyme elevations (R value 2 to 5) on the majority of samples tested during the acute illness
2 Latency of 4 to 24 weeks
3 Symptoms (if present) of nausea, fatigue, dark urine or pruritus early during course
4 Alkaline phosphatase levels greater than 3 times ULN (>345) at the time of peak ALT or bilirubin elevation
5 Bilirubin >2.5 mg/dL
6 If liver biopsy is obtained, changes of intrahepatic cholestasis with inflammatory cells accompanied by moderate to severe hepatocellular necrosis.

A latency above 24 weeks or alkaline phosphatase levels of only 2 times ULN (between 230 and 345 IU/L) while ALT levels are less than 400 IU (<10 times ULN) do not exclude but make the diagnosis less probable. Mixed forms of drug induced liver injury can present with immunoallergic features, particularly with a short incubation period or upon reexposure to the medication. Mixed cholestatic-hepatocellular liver injury is less likely to lead to acute liver failure or death from acute drug induced liver injury than is acute hepatitis due to medications. On the other hand, mixed hepatitis can evolve into a more cholestatic hepatitis than can be prolonged and evolve into vanishing bile duct syndrome. Prolonged cholestasis can be debilitating and contribute to multiorgan failure and death in patients with other serious underlying illnesses.

## Representative Cases

### Case 1. "Mixed" acute immunoallergic hepatitis due to phenytoin.

[Modified from: Gloria L, Serejo F, Cruz E, Freitas J, Costa A, Ramalho F, Batista A, de Moura MC. Diphenylhydantoin-induced hepatitis: a case report. Hepatogastroenterology1998; 45: 411-4. PubMed Citation]

A 25 year old man was started on phenytoin (100 mg thrice daily) for new onset seizures and developed fever, mobilliform pruritic rash and fatigue 3 weeks later. He was treated symptomatically and maintained on anticonvulsant therapy until 2 weeks later, when he was admitted for worsening rash and jaundice. He had no other medical illnesses, no history of liver disease, drank little alcohol and was taking no other medications except salicylates for fever. On examination, he had a generalized erythematous rash and facial edema. His temperature was 39.5 °C and he had mild cervical, axillary and inguinal adenopathy. He was jaundiced but had no hepatomegaly or peripheral signs of liver disease. Laboratory tests showed elevations in serum enzymes and bilirubin (Table). The total white count was 18,200/mm3 with 13% eosinophils and 13% atypical lymphocytes. An abdominal ultrasound was normal without splenomegaly or biliary abnormalities. He tested negative for markers of hepatitis A, B and C as well as cytomegalovirus, Epstein-Barr and herpes simplex viruses. Serological tests for syphilis were negative. Phenytoin was stopped. Initially, the prothrombin time was prolonged (20.4 sec, control 11 sec), but it corrected in the following week (and after vitamin K injections). The skin rash became desquamative. A liver biopsy showed changes of acute hepatitis with some granulomata and moderate cholestasis. In follow up six weeks after onset, the rash had resolved, he was asymptomatic and all laboratory tests (white counts and liver tests) were normal.

#### Key Points

Medication: | Phenytoin (100 mg three times daily)
Pattern: | Mixed (R=4.9)
Severity: | 4+ (hospitalization for jaundice, abnormal prothrombin time)
Latency: | 3 weeks to symptoms, 5 weeks to jaundice
Recovery: | Complete within 6 weeks
Other medications: | Salicylates for fever

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Prothrombin Time (seconds)
5 weeks | 0 | 888 | 570 | 4.8 | 20.4
5.5 weeks | 4 days | 1070 | 482 | 6.9 | 17.0
6 weeks | 7 days | 673 | 474 | 3.2 | 13.1
6.5 weeks | 10 days | 247 | 316 | 2.9 | 11.0
7 weeks | 13 days | 102 | 213 | 1.6 | 12.0
11 weeks | 6 weeks | Normal | Normal | Normal
Normal Values | | <29 | <90 | <1.2 | <14

#### Comment

The patient developed a typical acute anticonvulsant hypersensitivity syndrome with fever, rash, facial edema and lymphadenopathy within 3 weeks of starting phenytoin. Signs and symptoms of hepatitis arose thereafter and phenytoin was stopped once jaundice appeared. This pattern of onset and association with immunoallergic manifestations is typical of phenytoin hepatic injury and is often referred to as anticonvulsant hypersensity syndrome or drug rash with eosinophilia and systemic symptoms (DRESS) syndrome. The enzyme pattern was "mixed" hepatocellular-cholestatic pattern and the liver biopsy showed a similar pattern. The hepatic injury was severe but rapidly reversible once phenytoin was stopped, the reversal beginning ~7 days after stopping, which is typical of phenytoin hepatic injury. The prominence of the alkaline phosphatase elevations makes viral hepatitis unlikely as the cause of jaundice. An important diagnosis to exclude is mononucleosis hepatitis.

### Case 2. Mixed hepatocellular-cholestatic liver injury due to pioglitazone.

[Modified from: May LD, Lefkowitch JH, Kram MT, Rubin DE. Mixed hepatocellular-cholestatic liver injury after pioglitazone therapy. Ann Intern Med 2002; 136: 449-52. PubMed Citation]

A 49 year old man with type 2 diabetes and poor control with glyburide and metformin was started on pioglitazone, which was slowly increased in dose. Six months later, he developed jaundice and was found to have marked elevations in both serum aminotransferase and alkaline phosphatase levels (Table). There was no fever, rash or eosinophilia. He had had intermittent nausea and abdominal discomfort during pioglitazone therapy, but liver tests were previously normal. He had no history of liver disease or risk factors for hepatitis. Tests for hepatitis A, B and C were negative as were autoantibodies. A liver biopsy showed cholestasis, portal inflammation and mild bile duct damage suggestive of mixed pattern of injury due to drug hepatotoxicity. Pioglitazone was stopped on admission and he improved rapidly, all tests becoming normal within the following 6 weeks.

#### Key Points

Medication: | Pioglitazone (15-45 mg daily for 6 months)
Pattern: | Mixed (R=2.1)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 6 months
Recovery: | 6 weeks
Other medications: | Metformin, glyburide, lisinopril and omeprazole chronically (continued during admission)

#### Laboratory Values

Time After Starting | Days After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Pre | Pre | 30 | 30 | 0.6
Pioglitazone given for 6 months
6 months | 0 | 218 | 312 | 5.7 | Pioglitazone stopped
| 3 days | 487 | 617 | 10.4
| 7 days | 665 | 251 | 3.5 | Liver biopsy: mixed injury
6.5 months | 17 days | 372 | 36 | 2.4
7 months | 6 weeks | 30 | 30 | 0.6
Normal Values | | <40 | <116 | <1.2

* Values estimated from Figure 2 and converted to U/L and mg/dL.

#### Comment

The acute hepatitis was characterized by prominent elevations in ALT and alkaline phosphatase levels, which is not typical of acute viral hepatitis and is suggestive of a drug induced liver injury. In this instance, the injury was self limited and recovery was rapid. Drugs that can cause a "mixed" pattern of serum enzyme elevations, frequently have also been associated with either cholestatic or hepatocellular injury or both. It is uncommon for a drug to cause a mixed pattern of injury only.

### Case 3. Mixed hepatocellular-cholestatic liver injury due to amoxicillin/clavulanate.

[DILIN Case: 109-1031]

A 78 year old woman with acute bronchitis was treated with a 10 day course of oral amoxicillin and clavulanic acid (875mg/125 mg) twice daily and developed symptoms of fatigue and tiredness 2 weeks later. Over the next few days, she developed dark urine and when seen in follow up by her private physician (4 weeks after stopping the antibiotic) was found to be jaundiced. She had no history of liver disease, alcohol abuse, or recent risk factors for viral hepatitis. Her other medical conditions included hypertension, hypercholesterolemia, obesity and depression for which she took atenolol, amlodipine, lisinopril, simvastatin, aspirin and escitalopram, all on a chronic basis for more than a year. She had had a cholecystectomy many years in the past. On presentation, she was jaundiced but had no fever, rash or enlargement of liver or spleen. Laboratory tests showed total serum bilirubin of 11.1 mg/dL, ALT 767 U/L and alkaline phosphatase 185 (R ratio=11.8). There was no eosinophilia. Tests for hepatitis A, B and C were negative. The antinuclear antibody was positive in a titer of 1:640, but IgG levels were normal (1152 mg/dL) and both smooth muscle and mitochondrial antibodies were negative. Over the next few days, she continued to worsen. A liver biopsy showed cholestasis, portal inflammation and plasma cells suggestive of either autoimmune or drug induced hepatitis. She developed marked pruritus and was started on prednisone. Serum bilirubin peaked two weeks after admission at 30.0 mg/dL, at which time ALT was 262 U/L and alkaline phosphatase 141 (R ratio=3.1). In follow up, her symptoms resolved and her liver tests fell into the normal range. The dose of prednisone was slowly decreased and then stopped. Her liver tests remained in the normal range.

#### Key Points

Medication: | Amoxicillin/clavulanate (875/125)
Pattern: | Initially hepatocellular (R=11.2), then mixed (R=4.3)
Severity: | 3+ (jaundice, prolonged)
Latency: | 3 weeks
Recovery: | 4 months
Other medications: | Atenolol, amlodipine, lisinopril, simvastatin, aspirin and escitalopram chronically (continued)

#### Laboratory Values

Time After Starting | Time After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
5 weeks | 25 days | 767 | 185 | 11.1 | Presentation: R=11.8
6 weeks | 32 days | 424 | 135 | 21.9 | Liver Biopsy: R=5.3
| 35 days | 371 | 145 | 20.0 | Prednisone started: R=4.3
7 weeks | 41 days | 262 | 141 | 30.0 | R=3.1
8 weeks | 7 weeks | 88 | 105 | 2.2 | R=2.4
16 weeks | 15 weeks | 206 | 148 | 1.6
~5 months | 5 months | 33 | 79 | 0.8 | Prednisone stopped
~8 months | 8 months | 14 | 59 | 1.0
Normal Values | | <65 | <90 | <1.2

* Values estimated from Figure 2 and converted to U/L and mg/dL.

#### Comment

Amoxicillin/clavulanate is the most common cause of clinically apparent drug induced liver injury with jaundice in the United States and much of the Western world. The cause often goes misdiagnosed because the injury arises after the antibiotic is stopped. In this and a good proportion of cases, jaundice arises several weeks after stopping and the course of antibiotics may have been forgotten (or the incorrect antibiotic mentioned by the patient). The injury is usually "cholestatic" but is commonly "hepatocellular" at the onset, at least as defined by the R ratio comparing the degree of elevation of ALT to alkaline phosphatase. This case demonstrates that the hepatocellular injury is rapidly followed by a more mixed and even cholestatic ratio. In this instance, the injury was self limited but jaundice was prolonged and led to treatment with prednisone. The patient eventually recovered and was able to stop the corticosteroids without recurrence of injury. Drugs that can cause a "mixed" pattern of serum enzyme elevations are frequently also associated with either cholestatic or hepatocellular injury patterns or both. It is uncommon for a drug to cause a mixed pattern of injury only. This case demonstrates that the designation of a case as hepatocellular, mixed or cholestatic it is also dependent upon when blood sample is taken that is used to calculate the R ratio. From a clinical point of view, this case was cholestatic (deep jaundice and itching) and it is defined as "mixed" only because that the majority of values of ALT and alkaline phosphatase yielded R ratios between 2 and 5.

## Hepatic Histology of Mixed Hepatitis

[Under Construction]